# Metaxalone

## OVERVIEW

### Introduction

Metaxalone is a centrally acting skeletal muscle relaxant that has been in use for more than 40 years. Metaxalone has not been associated with serum aminotransferase elevations during therapy or with clinically apparent hepatic injury.

### Background

Metaxalone (me tax' a lone) acts centrally as a skeletal muscle relaxant, but its efficacy and precise mechanism of action are not well documented. Metaxalone was approved for use in the United States in 1962 and has been a widely used muscle relaxant, but its use recently has declined. Current indications include the treatment of pain from acute musculoskeletal conditions and muscle spasms. The recommended dosage is 800 mg orally three to four times daily. Metaxalone is available by prescription only in 400 and 800 mg tablets in generic forms as well as under the commercial name Skelaxin. Sparse data are available regarding metaxalone safety. Side effects are not common, but can include drowsiness, dizziness, headache, nausea, and dry mouth. When combined with other serotonergic medications (such as serotonin reuptake inhibitors, tricyclic antidepressants, triptans, opiates and others), metaxalone can cause acute serotonin syndrome marked by agitation, confusion, hallucinations, tachycardia, hyperthermia, incoordination, neuromuscular rigidity, nausea and abdominal pain.

### Hepatotoxicity

According to the product brochure, metaxalone may cause jaundice, although there are no specific case reports of hepatotoxicity from metaxalone in the literature and no prospective trials with routine monitoring of aminotransferase levels. Given its long history, metaxalone appears to be without significant hepatotoxicity.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

Drug Class: Muscle Relaxants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metaxalone – Generic, Skelaxin®

DRUG CLASS

Muscle Relaxants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=metaxalone)

Product Labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Metaxalone | 1665-48-1 | C12-H15-N-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 13 September 2021

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999; dantrolene, chlorzoxazone and baclofen are discussed; mentions that metaxalone has been cited as causing jaundice but that no such case reports have appeared in the literature).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics)
Toth PP, Urtis J. (2004). Commonly used muscle relaxant therapies for acute low back pain: a review of carisoprodol, cyclobenzaprine hydrochloride, and metaxalone. Clin Ther. (A review of safety and efficacy of muscle relaxants which states "Although rare instances of hepatic enzyme elevation and anemia have been reported [with metaxalone], this association appears to be based on a false-positive hepatic assay using the cephalin flocculation test.").
Chou R, Peterson K, Helfand M. (2004). Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants).
Moore KA, Levine B, Fowler D. (2005). A fatality involving metaxalone. Forensic Sci Int. (54 year old woman found dead in whom postmortem analysis indicated metaxalone overdose; liver reported as being normal).
Poklis JL, Ropero-Miller JD, Garside D, Winecker RE. (2004). Metaxalone (Skelaxin)-related death. J Anal Toxicol. (21 year old woman found dead in whom postmortem analysis indicated metaxalone overdose; no mention of liver abnormalities, although highest levels of drug were present in liver).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to muscle relaxants).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was attributed to chlorzoxazone, but none to metaxalone).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to metaxalone or other muscle relaxants).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to metaxalone or other muscle relaxants).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants, one of which was possibly related to metaxalone).
Li Y, Delcher C, Reisfield GM, Wei YJ, Brown JD, Winterstein AG. Utilization patterns of skeletal muscle relaxants among commercially insured adults in the United States from 2006 to 2018. Pain Med. 2021:pnab088. Epub ahead of print. (Analysis of utilization of skeletal muscle relaxants in the US over a 12 year period demonstrated an increasing use of cyclobenzaprine [65% of prescriptions], baclofen and tizanidine but decreasing use of metaxalone and carisoprodol).

## OTHER REFERENCE LINKS

1 Recent References on Metaxalone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Metaxalone/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Metaxalone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Metaxalone)